# Mebendazole

## OVERVIEW

### Introduction

Mebendazole is an anthelmintic agent used commonly for roundworm (pinworm and hookworm) infections, trichinosis, capillariasis and toxocariasis and other parasitic worm infections. Mebendazole when given for prolonged periods in high doses has been associated with elevations in serum enzyme levels, and rare instances of acute, clinically apparent liver injury have been linked to its use.

### Background

Mebendazole (me ben' da zole) is a benzimidazole anthelmintic similar in structure and mechanism of action to thiabendazole and albendazole. The benzimidazoles act by selective binding to beta-tubulin of parasitic worms, causing their immobilization and death. Mebendazole and albendazole share similar anthelmintic activity, mebendazole generally being preferred for treatment of pinworm and roundworm infections, and albendazole (because it is better absorbed) for systemic parasitic infections such as echinococcosis and cysticercosis. Mebendazole was approved for use in the United States in 1974 and is indicated for therapy of common parasitic worm infections. Mebendazole is available generically and under the brand names Emverm and Vermox in 100 mg and 500 mg chewable tablets. The usual dose is 100 or 500 mg once (pinworm) or varying doses for 3 days (whipworm, hookworm and roundworm infections), or varying doses for longer periods, depending upon the indication. Side effects with single dose regimens are uncommon, but can include gastrointestinal upset, fever, headache, nausea, vomiting and diarrhea. With more extended therapy, gastrointestinal symptoms are the most frequent side effects, and rare but potentially severe adverse effects include neutropenia, hypersensitivity reactions, hepatitis, angioedema, Stevens Johnson syndrome, and toxic epidermal necrolysis.

### Hepatotoxicity

Mebendazole when given in typical doses has not been associated with serum enzyme elevations, although the duration of therapy is usually short and monitoring for enzyme elevations has rarely been reported. With high dose therapy (which is now rarely used with the availability of albendazole), elevations in serum aminotransferase levels (2 to 10 times normal) can occur, but are usually well tolerated. There have been rare reports of acute liver injury due to mebenazole, particularly when it is given repeatedly or in higher doses. The onset is usually with fever and malaise within days of starting or restarting therapy. The pattern of serum enzyme elevations is typically hepatocellular, and jaundice is uncommon. The abnormalities usually resolve rapidly with stopping therapy. Signs of hypersensitivity (rash, fever and eosinophilia) are typical, and liver biopsy may show granulomas.

Likelihood score: C (probable cause of clinically apparent liver injury with extended therapy).

### Mechanism of Injury

Mebendazole acts by binding tubulin in parasitic worms, which it does with greater avidity than the tubulin in mammalian cells, but some of the toxicity of the benzimidazoles may be related to this tubulin-binding activity. In most instances of clinically apparent liver injury, hypersensitivity appears to be the cause.

### Outcome and Management

Mebendazole is usually well tolerated and the liver injury reported with its use has been mild and self-limited in course. Patients with hypersensitivity and acute liver injury attributed to mebendazole should avoid repeat exposure. Cross sensitivity to liver injury with other benzimidazoles (such as albendazole) has been reported but is not invariable. If a switch to another benzimidazole is done, patients should be monitored carefully for the first several months. If possible, switching to another class of anthelmintic agents is appropriate if therapy is still needed.

Drug Class: Anthelmintic Agents

## CASE REPORT

### Case 1. Acute liver injury due to mebendazole.(1)

A 52 year old Belgian man was treated with mebendazole (100 mg twice daily) for 3 days for suspected ascariasis. Fourteen days later the course was repeated, but within 2 days of restarting mebendazole he developed fever (39 ^o^C), diarrhea, poor appetite and fatigue. Because of the fever, he was given a 5 day course of cefuroxime, but remained febrile and symptomatic and was then found to have elevations in serum aminotransferase levels, with normal serum bilirubin and alkaline phosphatase (Table). He had eosinophilia (18%: absolute count 2,286/μL). Tests for hepatitis A, B and C were negative. He had low levels of antinuclear antibody (ANA: 1:40) and smooth muscle antibody (SMA: 1:160), but total globulin levels were normal. Ultrasound of the abdomen was negative. Stools were negative for ova and parasites. A liver biopsy showed multiple granulomas with multinucleate cells and active inflammation. There were no ova or helminths visualized and special stains for mycobacteria were negative. He improved rapidly without further therapy and 3 months later serum enzymes were normal.

#### Key Points

Medication: | Mebendazole (100 mg twice daily) for ~5 days
Pattern: | Hepatocellular (R=9.7)
Severity: | 1+ (enzyme elevations without jaundice)
Latency: | 26 days after initial course, 2 days of second course
Recovery: | Within 3 months
Other medications: | Cefuroxime (after onset of symptoms)

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
0 | Mebendazole (100 mg twice daily for 3 days)
14 | Mebendazole (100 mg twice daily for 2 days)
16 | 0 | Fever and rash
26 | 10 | 466 | 170 | 1.0 | Eosinophilia
28 | 12 | 540 | | | Liver biopsy
100 | 90 | Normal | Normal | Normal | No symptoms
Normal Values | | <48 | <60 | <1.2

#### Comment

Acute hepatocellular injury arose concurrent with symptoms and signs of hypersensitivity (rash and fever) within days of starting a second course of mebendazole. This pattern is typical of immunoallergic hepatitis and usually resolves rapidly, but can be severe if there is reexposure. The ANA and SMA titers may have been stimulated by the acute injury; in the absence of hyperglobulinemia were not compatible with autoimmune hepatitis. The granulomas found on liver biopsy reflect the generalized hypersensitivity and similar granulomas are likely to be found in other organs (lymph nodes, spleen).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mebendazole – Generic, Vermox®

DRUG CLASS

Anthelmintic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=mebendazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Mebendazole | 31431-39-7 | C16-H13-N3-O3

## CITED REFERENCE

1 Colle I, Naegels S, Hoorens A, Hautekeete M. Granulomatous hepatitis due to mebendazole. J Clin Gastroenterol 1999; 28: 44-5.9916665

## ANNOTATED BIBLIOGRAPHY

References updated: 20 April 2026

Zimmerman HJ. Anthelminthics. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 626-8. (Expert review of hepatotoxicity of anthelmintics written in 1999; mebendazole produces hepatic injury in dogs and occasionally in humans by uncertain mechanisms).
Keiser J, McCarthy J, Hotez PJ. Chemotherapy of helminth infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1001-7. (Textbook of pharmacology and therapeutics).
Polzin DJ, Stowe CM, O'Leary TP, Stevens JB, Hardy RM. Acute hepatic necrosis associated with the administration of mebendazole to dogs. J Am Vet Med Assoc 1981; 179: 1013-6. (Four of 10 Dachshunds treated with mebendazole [22 mg/kg for 3-5 days] developed acute hepatitis 8-10 days after stopping therapy [bilirubin 14.2 mg/dL, ALT 17 times ULN, Alk P 8 times ULN], and two died of multiorgan failure, autopsy showing centrolobular coagulative necrosis). 7341557
Swanson JF, Breider MA. Hepatic failure following mebendazole administration to a dog. J Am Vet Med Assoc 1982; 181: 72-3. (Four year old Labrador Retriever developed liver injury [bilirubin 8.1 mg/dL, ALT 8 times ULN, Alk P 5 times ULN] starting 3 days after a second course of mebendazole [22 mg/kg], autopsy showing centrolobular hepatic necrosis). 7107495
Seitz R, Schwerk W, Arnold R. [Hepatocellular drug reaction caused by mebendazole therapy in cystic echinococcosis]. Z Gastroenterol 1983; 21: 324-9. German. (76 year old man with Echinococcal cysts of liver developed rash 49 days after starting mebendazole [~29 mg/kg/day], with ALT 250 U/L but normal bilirubin and Alk P; positive rechallenge to low dose [ALT 403 U/L]). 6613213
Junge U, Mohr W. [Mebendazole-hepatitis]. Z Gastroenterol 1983; 21: 736-8. German. (Among 29 patients with echinococcosis treated with mebendazole, 1 developed hepatitis; 53 year old woman noted dark urine 2 months after starting therapy [bilirubin 2.1 mg/dL, ALT 475 U/L, Alk P 270 U/L]; biopsy showing spotty necrosis, resolving in 1.5 months; positive rechallenge [ALT 400 U/L, Alk P 358 U/L]). 6666188
Mousa AM, Rudwan MA, Marafi AA, Muhtaseb SA, Dajani AI. Human cystic hydatid disease: treatment with interrupted courses of mebendazole. J Trop Med Hyg 1986; 89: 257-64. (10 patients with echinococcal cysts were treated with high doses of mebendazole [1800 mg/day] for up to 18 weeks; a 37 year old woman with multiple cysts developed jaundice at 11 days that became cholestatic but ultimately resolved; few details given and referred to as “amoebic hepatitis”). 3795326
Bekhti A, Pirotte J. Hepatotoxicity of mebendazole. Relationship with serum concentrations of the drug. Gastroenterol Clin Biol 1987; 11: 701-3. (47 year old woman with hydatid cysts in the liver developed persistent elevations in ALT [60-400 U/L] and Alk P [207 U/L] without jaundice during a third course of mebendazole given in high doses [4.5-6.0 g daily], ALT levels correlated with serum mebendazole levels, normalized with stopping and rose again with rechallenge apparently without symptoms or jaundice). 3692093
Colle I, Naegels S, Hoorens A, Hautekeete M. Granulomatous hepatitis due to mebendazole. J Clin Gastroenterol 1999; 28: 44-5. (52 year old man treated with mebendazole for 3 days on two occasions 2 weeks apart developed fever during the second course and then found to have bilirubin 1.0 mg/dL, ALT 466 U/L, Alk P normal, 18% eosinophils and liver biopsy showing granulomas; no jaundice and rapid recovery: Case 1). 9916665
Reuter S, Jensen B, Buttenschoen K, Kratzer W, Kern P. Benzimidazoles in the treatment of alveolar echinococcosis: a comparative study and review of the literature. J Antimicrob Chemother 2000; 46: 451-6. (35 patients with alveolar echinococcosis were treated with either mebendazole or albendazole for 12-79 months; no severe side effects, but one patient was switched from albendazole to mebendazole because of ALT elevations). 10980173
Keiser J, Utzinger J. Efficacy of current drugs against soil-transmitted helminth infections: systematic review and meta-analysis. JAMA 2008; 299: 1937-48. (Systematic review of efficacy and safety of albendazole, mebendazole and pyrantel pamoate as therapy of Ascaris lumbricoides [roundworm], hookworm and whipworm; mebendazole was well tolerated in most studies, no significant adverse events were reported). 18430913
Drugs for parasitic infections. Treat Guidel Med Lett 2013; 11 (Suppl): e1-31. (Thorough description of drugs for parasitic infections in adults and children as well as a table of their major side effects; mebendazole can be used for ascariasis, pinworm, hookworm, whipworm, trichinellosis, and several less common parasitic infections; no hepatic related side effects mentioned).
Mandal S, Mandal MD. Human cystic echinococcosis: epidemiologic, zoonotic, clinical, diagnostic and therapeutic aspects. Asian Pac J Trop Med 2012; 5: 253-60. (Review of human enchinococcal cyst disease, its epidemiology, clinical manifestations, diagnosis, prevention and treatment which includes direct aspiration and surgery on the cysts and medical therapy with either mebendazole, albendazole or ivermectin often with praziquantel; no discussion of side effects). 22449514
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to mebendazole or other anthelminthic medications). 25754159
Silber SA, Diro E, Workneh N, Mekonnen Z, Levecke B, Steinmann P, Umulisa I, et al. Efficacy and Safety of a single-dose mebendazole 500 mg chewable, rapidly-disintegrating tablet for Ascaris lumbricoides and Trichuris trichiura infection treatment in pediatric patients: a double-blind, randomized, placebo-controlled, phase 3 study. Am J Trop Med Hyg. 2017;97:1851-1856. (Among 295 children [ages 1 to 15 years] with hookworm infection treated with mebendazole [single 500 mg chewable tablet] vs placebo, cure rates were 84% vs 11% for Ascaris lumbricoides and 34% vs 8% for Trichuris trichiuria, while adverse events arose in 6.3% vs 5.7%, mostly mild-to-moderate abdominal pain or distension, with no serious adverse events or deaths). 29016336
Palmeirim MS, Ame SM, Ali SM, Hattendorf J, Keiser J. Efficacy and safety of a single dose versus a multiple dose regimen of mebendazole against hookworm infections in children: a randomised, double-blind trial. EClinicalMedicine. 2018 Jul; 1: 7-13. (Among 185 children with hookworm infestation [Ancylostoma duodenale] treated with mebendazole in a dose of 100 mg twice daily for 3 days vs a single 500 mg dose, cure rates were 98% vs 13%, while adverse events were similar consisting of mild-to-moderate abdominal pain, diarrhea and headache). 31193620
Cañete R, Brito K, Brito I, Semper A, Gonzalez ME. Effectiveness and tolerability of 3-day mebendazole treatment of Giardia duodenalis infection in adults and children: two prospective, open-label phase IV trials. Curr Ther Res Clin Exp. 2018; 89: 43-47. (Among 522 children and 423 adults with giardia duodenalis infection treated in two open-label trials of a 3-day regimen of mebendazole [100 mg twice daily] in Cuba, cure rates were 86% and 93% and adverse events were abdominal pain [6% in both groups], nausea and vomiting [in 2-3% of children]). 30792825
Tolomeo M, Colomba C, Meli M, Cascio A. Hepatotoxicity caused by mebendazole in a patient with Gilbert's syndrome. J Clin Pharm Ther. 2019;44:985-987. (58 year old man with pinworm infestation developed fever, anorexia, and jaundice after 3 weekly 3 day courses of mebendazole [200 mg daily] with total bilirubin 3.4 mg/dL, direct 0.8 mg/dL, ALT 612 U/L, and Alk P normal, and with rapid resolution 5 weeks after stopping). 31423600
Palmeirim MS, Bosch F, Ame SM, Ali SM, Hattendorf J, Keiser J. Efficacy, safety and acceptability of a new chewable formulation versus the solid tablet of mebendazole against hookworm infections in children: An open label, randomized controlled trial. EClinicalMedicine. 2020; 27: 100556. (Among 397 children [ages 3 to 12 years] with hookworm treated with a single dose of mebendazole in a solid vs chewable tablet form [500 mg], cure rates were similar [71% vs 69%] and adverse events were uncommon and mostly mild fever, headache, abdominal pain and nausea; no mention of hepatoxicity). 33150325
Dragutinović N, Barać A, Stevanović G, Đorđić I, Paglietti B, Micić J, Aleksić E, et al. Acute hepatitis in a paediatric patient: immune-mediated drug-induced liver injury or albendazole-induced autoimmune hepatitis? J Infect Dev Ctries. 2022;16:1660-1663. (Eight year old girl with urticaria and pinworm infection developed nausea and fever 3 days after starting albendazole which resolved on stopping and 20 days later developed nausea and dark urine 3 days after starting mebendazole, laboratory data not provided but she was jaundiced and had complete resolution after stopping the second benzimidazole). 36332223
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 5 [1%] were attributed to albendazole, 1 to mebendazole, but none to fenbendazole). 38992407
Muana Wilhelm L, Bachmann J, Cornberg M, Wedemeyer H, Heinrich B. Hepatotoxizität durch Albendazol: sichere Alternativen bei Echinokokkosetherapie [Hepatotoxicity due to albendazole: safe alternatives for echinococcosis therapy]. Inn Med (Heidelb). 2025;66:231-235. German. PMID: 39313604 (72 year old man with a large Echinococcal cyst developed abdominal pain and liver injury 6 weeks after starting albendazole [ALT 338 U/L, Alk P 164 U/L, bilirubin not given] with resolution within 19 days of stopping and no recurrence when switched to mebendazole with dose gradually increased to 4 gm daily with total treatment of 20 months and cyst shrinkage).

## OTHER REFERENCE LINKS

1. Recent References on Mebendazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Mebendazole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Mebendazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mebendazole)